# Tocilizumab

## OVERVIEW

### Introduction

Tocilizumab is a humanized monoclonal antibody to the interleukin-6 (IL-6) receptor which is used in the therapy of rheumatoid arthritis and other autoinflammatory conditions. Tocilizumab commonly causes mild serum aminotransferase elevations that are usually short lived and asymptomatic, but has also been linked to rare instances of clinically apparent liver injury with jaundice and occasional reactivation of hepatitis B.

### Background

Tocilizumab (toe” si liz’ ue mab) is a humanized IgG1 monoclonal antibody to the IL-6 receptor that is used largely as therapy of refractory rheumatoid arthritis and other inflammatory arthritides. Tocilizumab blocks the action of IL-6, which is a key proinflammatory cytokine that mediates a wide spectrum of biologic activities including activation of T cells, differentiation of B cells, induction of acute phase reactants, proliferation of fibroblasts, and damage to cartilage and joints. IL-6 levels are elevated in patients with active rheumatoid arthritis. In controlled trials and open label studies, tocilizumab therapy led to improvements in symptoms and laboratory abnormalities associated with several forms of inflammatory arthritis. Tocilizumab was approved for use in the United States in 2010 and current indications include rheumatoid arthritis, giant cell arteritis and both the polyarticular and systemic forms of juvenile idiopathic arthritis (formerly juvenile rheumatoid arthritis). Tocilizumab is considered a disease modifying antirheumatic drug (DMARD) and improves signs and symptoms of disease and decreases cartilage and tissue destruction. More recently, tocilizumab has also been approved as therapy of the cytokine release syndrome in children. Because of its effects on cytokine release syndrome and ability to lower levels of IL-6, tocilizumab has been evaluated as therapy of the hyperinflammatory phase of severe COVID-19 infection. In December 2020, tocilizumab was given emergency use authorization as therapy of hospitalized patients with severe COVID-19 pneumonia on invasive mechanical ventilation or extracorporeal membrane oxygenation (ECMO). Tocilizumab is typically given by intravenous infusion every 4 weeks, in doses of 4-12 mg/kg depending upon indication and body weight. For intravenous use, tocilizumab is available in single dose vials of 80, 200 and 400 mg (20 mg/mL) under the brand name Actemra. Subcutaneous forms of tocilizumab are also available that can be substituted for the intravenous dosing as single use vials of 162 mg in 0.9 mL. The most frequent side effects are upper respiratory symptoms, headache, infusion reactions and hypertension. Uncommon but potentially severe adverse effects include severe infections, reactivation of tuberculosis and viral infections, gastrointestinal perforation, hepatotoxicity and hypersensitivity reactions including anaphylaxis.

### Hepatotoxicity

In registration trials, serum aminotransferase elevations occurred in a high proportion (10% to 50%) of patients receiving tocilizumab. ALT elevations often rose to 1 to 3 times the upper limit of normal (ULN) 2 weeks after each infusion, but decreased towards baseline by the time of the next 4-weekly administration and were usually normal within 8 weeks of stopping the infusions. In some instances (~1% to 2%), levels rose above 5 times the ULN which triggered discontinuation or temporary suspension of treatment. Interestingly, the ALT elevations were somewhat dose related and tended to recur, but did not worsen with repeated exposures. In preapproval registration trials, there were no reports of clinically apparent liver injury with jaundice, and most ALT elevations were without symptoms and with minimal or no elevations in serum bilirubin or alkaline phosphatase levels. Since its licensure and availability, however, tocilizumab therapy has been linked to several instances of clinically apparent liver injury with jaundice. The injury arose after several months of therapy and was predominantly hepatocellular with no immunoallergic or autoimmune features. While the liver injury was severe, it was usually self-limited with complete recovery in 2 to 3 months. In at least one instance, however, the affected patient died with liver failure and hepatic atrophy that seemed to be initiated by tocilizumab therapy. In studies of tocilizumab as therapy of severe COVID-19 pneumonia, elevations in serum aminotransferase levels have been reported but at rates similar to those in control groups. There have been no reports of severe liver injury with jaundice or reactivation of hepatitis B attributed to tocilizumab therapy in these critically ill patients enrolled several large clinical trials.

Tocilizumab is an immunosuppressive agent, but has only rarely been implicated in causing reactivation of viral infections such as cytomegalovirus and hepatitis B. Most cases of HBV reactivation have occurred in persons with preexisting HBsAg and who did not receive antiviral prophylaxis. In patients with anti-HBc without HBsAg in serum, suggesting recovery from previous hepatitis B, tocilizumab rarely causes reactivation and most cases have been mild and subclinical. In several cases reports, tocilizumab has been used safety and without worsening of disease in patients with concurrent chronic hepatitis C, but there has been at least one case report of mild and transient worsening of hepatitis C with its use.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

Tocilizumab is a monoclonal antibody and has minimal hepatic metabolism. The mechanism by which it causes liver injury is unknown, but may be the result of its effects on the immune system or on the IL-6 pathway which is important in liver regeneration.

### Outcome and Management

The mild liver injury caused by tocilizumab is generally short lived and resolves within 2 to 6 weeks. The majority of patients can continue the 4 weekly infusions, although dose reduction may be warranted. The more severe, clinically apparent liver injury caused by tocilizumab should trigger its permanent discontinuation. Current recommendations are that patients should be monitored with routine liver tests before starting tocilizumab, every 4 to 8 weeks for the first 6 months and every 3 months thereafter. The effects of reexposure to tocilizumab after clinically apparent liver injury have not been reported, but rechallenge should probably be avoided. On the other hand, there is no reason to suspect that there may be cross sensitivity to hepatic injury between tocilizumab and other immune modulating biologic agents or anti-IL1 blockers such as anakinra, canakinumab and rilonacept.

Drug Class: Antirheumatic Agents, COVID-19 Drugs

Other Drugs in the Subclass, Interleukin Receptor Antagonists: Anakinra, Canakinumab, Rilonacept, Sarilumab

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Tocilizumab – Actemra®

DRUG CLASS

Antirheumatic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=tocilizumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Tocilizumab | 375823-41-9 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 11 May 2021

Abbreviations: ULN, upper limit of normal.

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-53. (Expert review of hepatotoxicity published in 1999 before the availability of tocilizumab and other monoclonal antibodies and anticytokines).
Krensky AM, Azzi JR, Hafler DA. Immunosuppressants and tolerogens. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 637-53. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2010/125276s000MedR.pdf (FDA website with review of evidence for efficacy and safety of tocilizumab mentions that tocilizumab is associated with liver enzyme abnormalities but not with severe clinical liver injury, ALT elevations occurring in 39-52% of treated patients compared to 17% of placebo controls with elevations above 5 times ULN in less than 1% and no episodes of clinically apparent liver injury convincingly linked to tocilizumab).
Bywaters EG. (1971). Still's disease in the adult. Ann Rheum Dis. (Clinical description of 14 patients with adult Still disease seen at a single referral center in the UK over a 25 year period; all woman, ages 17 to 35 years, presenting with urticarial, macular rash, high fevers, fatigue and arthritis, high ESR but no rheumatoid factor, the majority ultimately recovering completely without residual arthritis or problems).
Andrès E, Kurtz JE, Perrin AE, Pflumio F, Ruellan A, Goichot B, Dufour P, et al. (2003). Retrospective monocentric study of 17 patients with adult Still's disease, with special focus on liver abnormalities. Hepatogastroenterology. (Among 17 patients with adult onset Still disease seen at a single French referral center, mean age was 27 years and 76% had moderate liver dysfunction with hepatomegaly in 47% [bilirubin 0.6-1.3 mg/dL, ALT 32-252 U/L], all having "complete recovery").
Maini RN, Taylor PC, Szechinski J, Pavelka K, Bröll J, Balint G, Emery P, et al., CHARISMA Study Group. (2006). Double-blind randomized controlled clinical trial of the interleukin-6 receptor antagonist, tocilizumab, in European patients with rheumatoid arthritis who had an incomplete response to methotrexate. Arthritis Rheum. (359 patients with active rheumatoid arthritis were randomized to different doses of tocilizumab or placebo with or without methotrexate; mild increases in ALT [by 45-88% from baseline] were common with the combination and with higher doses, but were transient and not associated with symptoms or jaundice).
Plushner SL. (2008). Tocilizumab: an interleukin-6 receptor inhibitor for the treatment of rheumatoid arthritis. Ann Pharmacother. (Review of pharmacology, clinically efficacy and safety of tocilizumab mentions that dose dependent liver enzyme elevations were frequent during therapy, but that "most levels returned to near normal at follow-up").
Feist E, Burmester GR. (2009). Is tocilizumab in combination with traditional DMARDs safe and effective for patients with active RA?. Nat Clin Pract Rheumatol. (Editorial mentions that liver enzyme elevations occur in 45% of patients treated with tocilizumab, but were transient and asymptomatic).
Nishimoto N, Miyasaka N, Yamamoto K, Kawai S, Takeuchi T, Azuma J. (2009). Long-term safety and efficacy of tocilizumab, an anti-IL-6 receptor monoclonal antibody, in monotherapy, in patients with rheumatoid arthritis (the STREAM study): evidence of safety and efficacy in a 5-year extension study. Ann Rheum Dis. (Among 143 patients with rheumatoid arthritis who were continued in an extension trial of tocilizumab for up to 5 years, serum ALT elevations [>2.5 times ULN] occurred in 10%, but most elevations were transient and there were no serious liver related adverse events).
Furst DE. (2010). The risk of infections with biologic therapies for rheumatoid arthritis. Semin Arthritis Rheum. (Review of the excess risk of infections during biologic therapy of rheumatoid arthritis mentions that the rate of infections was 2.1% in treated patients vs 0.4% in controls; infections were primarily pneumonia and skin infections, none were fatal and few were opportunistic).
Carroll MB. (2011). The impact of biologic response modifiers on hepatitis B virus infection. Expert Opin Biol Ther. (Review of reactivation of hepatitis B by biologic response modifiers; tocilizumab has not been linked to reactivation of HBV, although the experience in treating patients with HBsAg has been limited).
Schiff MH, Kremer JM, Jahreis A, Vernon E, Isaacs JD, van Vollenhoven RF. (2011). Integrated safety in tocilizumab clinical trials. Arthritis Res Ther. (Analysis of safety data from 5 large clinical trials and extension studies of tocilizumab in 8580 patients with rheumatoid arthritis treated for up to 5 years; ALT elevations occurred in 19-33% of patients and were above 3 times ULN in 1.1-3.7%, being more frequent with higher doses; dose reductions for ALT elevations occurred in 9.3% and stopping therapy in 2.3% of patients; however, "no evidence was seen of clinically significant hepatitis or drug-induced liver injury associated with transaminase elevations in patients treated with tocilizumab"; 11 liver biopsies showed either nonalcoholic fatty liver disease or were normal).
Koike T, Harigai M, Inokuma S, Ishiguro N, Ryu J, Takeuchi T, Takei S, et al. (2011). Postmarketing surveillance of tocilizumab for rheumatoid arthritis in Japan: interim analysis of 3881 patients. Ann Rheum Dis. (Evaluation of adverse event reports during the first 1.5 years of tocilizumab availability in Japan; among 3004 reports from 1641 patients, most common were infections followed by laboratory test abnormalities and "hepatobiliary disorders" [n=269 of which 12 were serious], but no details given).
Bannwarth B, Richez C. (2011). Clinical safety of tocilizumab in rheumatoid arthritis. Expert Opin Drug Saf. (Review of the adverse events reported in clinical trials of tocilizumab in rheumatoid arthritis; among 3689 patients with normal ALT levels before treatment, 10.3% had ALT elevations >3 times ULN and 2.4% above 5 times ULN, but there were no cases of clinical apparent liver injury).
Hiura M, Abe S, Tabaru A, Shimajiri S, Hanami K, Saito K, Tanaka Y, et al. (2011). Case of severe liver damage after the induction of tocilizumab therapy for rheumatoid vasculitis. Hepatol Res. (71 year old man with refractory rheumatoid arthritis and vasculitis developed mild serum enzyme elevations during 3 months of tocilizumab therapy [bilirubin 1.3 mg/dL, ALT 67 U/L, Alk P 380 U/L, platelets 93,000/μL], later developing ascites, and hepatic failure, autopsy showing hepatic atrophy and little fibrosis).
Lee JS, Wang J, Martin M, Germer S, Kenwright A, Benayed R, Spleiss O, et al. (2011). Genetic variation in UGT1A1 typical of Gilbert syndrome is associated with unconjugated hyperbilirubinemia in patients receiving tocilizumab. Pharmacogenet Genomics. (Two of 1187 patients with rheumatoid arthritis who developed a concurrent rise in ALT >3 times ULN and serum bilirubin >2 times ULN during tocilizumab therapy were both found to be homozygous for genetic variants of UGT1A1 associated with indirect hyperbilirubinemia and Gilbert syndrome).
Kishida D, Okuda Y, Onishi M, Takebayashi M, Matoba K, Jouyama K, Yamada A, et al. (2011). Successful tocilizumab treatment in a patient with adult-onset Still's disease complicated by chronic active hepatitis B and amyloid A amyloidosis. Mod Rheumatol. (40 year old man with hepatitis B and adult onset Still disease was treated with tocilizumab while receiving entecavir and did not have a rise in HBV DNA levels or worsening of liver disease during anti-IL6 therapy).
Mahamid M, Paz K, Reuven M, Safadi R. (2011). Hepatotoxicity due to tocilizumab and anakinra in rheumatoid arthritis: two case reports. Int J Gen Med. (46 year old woman with rheumatoid arthritis who was switched from methotrexate [10 years] to tocilizumab and developed fatigue after a 2nd infusion, a liver biopsy showing steatosis and "focal hemorrhagic necrosis" despite normal serum enzymes and bilirubin; later continuing tocilizumab without change in liver tests).
Mahamid M, Mader R, Safadi R. (2011). Hepatotoxicity of tocilizumab and anakinra in rheumatoid arthritis: management decisions. Clin Pharmacol. (Description of same two patients as in Mahamid [Int J Gen Med 2011]).
Iebba F, Di Sora F, Tarasi A, Leti W, Montella T, Montella F. (2012). Case report: safety and efficacy of tocilizumab in a patient with rheumatoid arthritis and chronic hepatitis C. Case Rep Med. (71 year old woman with chronic hepatitis C and rheumatoid arthritis refractory to therapy with methotrexate and anti-TNF agents was treated with tocilizumab with excellent response and no change in serum enzyme levels [which remained normal] during 6 months of treatment).
(2012). Drugs for rheumatoid arthritis. Treat Guidel Med Lett. (Concise summary on current therapies of rheumatoid arthritis mentions that side effects of tocilizumab include infusion reactions, hypertension, neutropenia, aminotransferase elevations and dyslipidemia).
De Benedetti F, Brunner HI, Ruperto N, Kenwright A, Wright S, Calvo I, Cuttica R, et al. (2012). PRINTO; PRCSG. Randomized trial of tocilizumab in systemic juvenile idiopathic arthritis. N Engl J Med. (Among 112 children with systemic juvenile idiopathic arthritis not responding to standard therapy in a 12 week, placebo controlled trial, ALT elevations occurred in 19% of 75 tocilizumab recipients [and were >5 times ULN in 7%], but in none of 37 placebo recipients).
Sandborg C, Mellins ED. (2012). A new era in the treatment of systemic juvenile idiopathic arthritis. N Engl J Med. (Editorial in response to De Benedetti [2012] on IL-6 antagonists as therapy of juvenile idiopathic arthritis; "the therapeutic benefits of these biologic agents will need to be weighed against the apparent risks of infection, neutropenia and liver dysfunction").
Nagashima T, Maruyama A, Kamata Y, Minota S. (2012). Unchanged serum viral load and liver function during tocilizumab treatment in a patient with rheumatoid arthritis and hepatitis C virus infection. Rheumatol Int. (53 year old Japanese man with rheumatoid arthritis and chronic hepatitis C was treated with tocilizumab for 6 months without worsening of his concurrent hepatitis C or change in ALT or HCV RNA levels).
Dragonas C, Ehrenstein B, Fleck M. (2012). Tocilizumab treatment in a patient suffering from rheumatoid arthritis and concomitant chronic hepatitis C infection. Rheumatology (Oxford). (47 year old man with rheumatoid arthritis and chronic hepatitis C tolerated tocilizumab therapy with no change in serum enzymes of HCV RNA levels during a full year of treatment).
Mori S, Fujiyama S. (2012). Comment on: Tocilizumab treatment in a patient suffering from rheumatoid arthritis and concomitant chronic hepatitis C infection. Rheumatology (Oxford). (Letter in response to Dragonas [2012] describing a 65 year old woman with rheumatoid arthritis and chronic hepatitis C who had a flare of disease [ALT 211 U/L, HCV RNA levels rising slightly, bilirubin not given] after 8 months of tocilizumab therapy, resolving upon stopping).
Akgul O, Kilic E, Kilic G, Ozgocmen S. (2013). Efficacy and safety of biologic treatments in familial Mediterranean Fever. Am J Med Sci. (Systematic review of reports on use of biologic response modifiers in familial Mediterranean fever identified no controlled trials, but 24 single reports and 7 case series describing 59 patients; agents evaluated included TNF antagonists [35], anakinra [29], and canakinumab [4], but not tocilizumab; no discussion of hepatotoxicity).
Gabay C, Emery P, van Vollenhoven R, Dikranian A, Alten R, Pavelka K, Klearman M, et al., ADACTA Study Investigators. (2013). Tocilizumab monotherapy versus adalimumab monotherapy for treatment of rheumatoid arthritis (ADACTA): a randomised, double-blind, controlled phase 4 trial. Lancet. (Controlled trial comparing 24 week courses of 2 monoclonal antibody therapies in 326 patients with rheumatoid arthritis; ALT elevations above 2.5 times ULN occurred in 6% on tocilizumab vs 1.9% on adalimumab, but there were no serious adverse events attributed to liver injury).
Alfreijat M, Habibi M, Bhatia P, Bhatia A. (2013). Severe hepatitis associated with tocilizumab in a patient with rheumatoid arthritis. Rheumatology (Oxford). (62 year old man with rheumatoid arthritis developed jaundice 1 week after a 3rd monthly injection of tocilizumab [bilirubin 10.5, ALT 2296, Alk P not given], resolving within 10 weeks on prednisone; accompanied by mild pancreatitis).
Drepper M, Rubbia-Brandt L, Spahr L. (2013). Tocilizumab-induced acute liver injury in adult onset Still's disease. Case Reports Hepatol. (18 year old woman with Still disease developed jaundice 6 months after starting tocilizumab [bilirubin 3.6 mg/dL, ALT 2628 U/L, Alk P 110 U/L, INR 1.21], with liver biopsy showing centrilobular necrosis, and resolving within 1 month of stopping).
Giannitti C, Fineschi I, Frediani B, Fioravanti A, Galeazzi M. (2013). Efficacy and safety of tocilizumab combined with cyclosporine A in a patient with rheumatoid arthritis and concomitant chronic hepatitis C virus infection. Clin Exp Rheumatol. (58 year old man with rheumatoid arthritis and chronic hepatitis C tolerated treatment with tocilizumab, cyclosporine and prednisone for 12 months with no worsening of ALT levels or increase in HCV RNA levels).
Genovese MC, Rubbert-Roth A, Smolen JS, Kremer J, Khraishi M, Gómez-Reino J, Sebba A, et al. (2013). Long-term safety and efficacy of tocilizumab in patients with rheumatoid arthritis: a cumulative analysis of up to 4.6 years of exposure. J Rheumatol. (Analysis of long term safety data from 5 controlled trials and open label extension studies of tocilizumab given for an average of 3 years in 4009 patients with rheumatoid arthritis; 3 hepatic serious adverse events occurred, autoimmune hepatitis, steatosis and hepatic ischemia, the last being possibly related as it occurred in a patient with an anaphylactic reaction).
Burmester GR, Rubbert-Roth A, Cantagrel A, Hall S, Leszczynski P, Feldman D, Rangaraj MJ, et al. (2014). A randomised, double-blind, parallel-group study of the safety and efficacy of subcutaneous tocilizumab versus intravenous tocilizumab in combination with traditional disease-modifying antirheumatic drugs in patients with moderate to severe rheumatoid arthritis (SUMMACTA study). Ann Rheum Dis. (Comparison of weekly subcutaneous injections to every 4 weekly intravenous infusions of tocilizumab in 1262 patients with rheumatoid arthritis; the safety profiles were similar except for injection site reactions; some degree of ALT elevation occurred in 52% of patients and were >3 times ULN in 5% and >5 times ULN in 1%).
Bauer H, Luxembourger C, Gottenberg JE, Fournier S, Abravanel F, Cantagrel A, Chatelus E, et al. (2015). Club Rhumatismes et Inflammation, a section of the French Society of Rheumatology. Outcome of hepatitis E virus infection in patients with inflammatory arthritides treated with immunosuppressants: a French retrospective multicenter study. Medicine (Baltimore). (Survey of French physicians treating patients with rheumatic diseases identified 23 patients who developed acute hepatitis E while being treated with immunosuppressive regimens [10 on anti-TNF, 4 rituximab, 2 abatacept, 2 tocilizumab and 16 receiving methotrexate, 4 leflunomide and 1 cyclosporine]; all recovered and cleared HEV RNA, some after reduction in immunosuppression and 5 with ribavirin therapy).
Curtis JR, Perez-Gutthann S, Suissa S, Napalkov P, Singh N, Thompson L, Porter-Brown B, Actemra Pharmacoepidemiology Board. (2015). Tocilizumab in rheumatoid arthritis: a case study of safety evaluations of a large postmarketing data set from multiple data sources. Semin Arthritis Rheum. (Analysis of large postmarketing databases on adverse reactions to tocilizumab combined with data on amounts of drug sold suggested that the rate of serious hepatic adverse events was 0.06 per 100 person-years of exposure [36 events in 31 patients]).
Nakamura J, Nagashima T, Nagatani K, Yoshio T, Iwamoto M, Minota S. (2016). Reactivation of hepatitis B virus in rheumatoid arthritis patients treated with biological disease-modifying antirheumatic drugs. Int J Rheum Dis. (Among 244 patients with rheumatoid arthritis started on biologic therapy at a single Japanese referral center, 57 [23%] had serologic evidence of previous HBV infection [anti-HBc without HBsAg in serum], of whom only 3 were identified as having HBV reactivation [including 2 of 18 on tocilizumab and 1 of 50 on anti-TNF agents] but HBV DNA levels were low, not associated with symptoms or liver test abnormalities and only transiently detectable despite continuation of therapy).
Komura T, Ohta H, Nakai R, Seishima J, Yamato M, Miyazawa M, Kaji K, et al. (2016). Cytomegalovirus reactivation induced acute hepatitis and gastric erosions in a patient with rheumatoid arthritis under treatment with an anti-IL-6 receptor antibody, tocilizumab. Intern Med. (54 year old woman with rheumatoid arthritis on prednisone and methotrexate developed fever and CMV viremia with liver test abnormalities 19 days after starting tocilizumab [bilirubin 1.3 mg/dL, ALT 106 U/L, Alk P 495 U/L], improving rapidly with ganciclovir therapy and having normal liver tests 8 weeks later).
Genovese MC, Kremer JM, van Vollenhoven RF, Alten R, Scali JJ, Kelman A, Dimonaco S, et al. (2017). Transaminase levels and hepatic events during tocilizumab treatment: pooled analysis of long-term clinical trial safety data in rheumatoid arthritis. Arthritis Rheumatol. (Among 4171 patients with rheumatoid arthritis treated in clinical trials with tocilizumab for an average of 3.9 years, routine monitoring showed at least one ALT abnormality in 71% but most were mild and transient and arose during the first year of therapy, only 3% were above 5 times ULN, 2.5% resulted in drug discontinuation and only 7 subjects had a severe hepatic adverse event [cirrhosis, acute liver failure, ascites, steatosis, ischemic hepatitis and autoimmune hepatitis], none of which were very convincingly linked to tocilizumab).
Anger F, Wiegering A, Wagner J, Lock J, Baur J, Haug L, Schmalzing M, et al. (2017). Toxic drug-induced liver failure during therapy of rheumatoid arthritis with tocilizumab subcutaneously: a case report. Rheumatology (Oxford). (51 year old woman with rheumatoid arthritis developed liver enzyme elevations 5 years after starting tocilizumab which continued to worsen despite stopping drug with jaundice arising 3 months later followed by progressive hepatic failure and liver transplantation).
Fromhold-Treu S, Erbersdobler A, Turan M, Neeck G, Lamprecht G. (2017). Z Gastroenterol. (41 year old woman with systemic lupus treated with prednisone, azathioprine or tocilizumab developed CMV hepatitis [bilirubin 14.8 mg/dL, ALT 430 U/L, Alk P 171 U/L, INR 2.1], resolving with increase in corticosteroid dose and valganciclovir).
Chen LF, Mo YQ, Jing J, Ma JD, Zheng DH, Dai L. (2017). Short-course tocilizumab increases risk of hepatitis B virus reactivation in patients with rheumatoid arthritis: a prospective clinical observation. Int J Rheum Dis. (Among 7 patients with rheumatoid arthritis and HBsAg in serum treated with 4 infusions of tocilizumab 1 month apart, 3 [of 5 without prophylaxis] developed reactivation of hepatitis B, which resolved rapidly and without ALT elevations with prompt antiviral therapy; of 41 patients with resolved HBV infection [anti-HBc without HBsAg], none developed reactivation).
Ikeuchi H, Koinuma K, Nakasatomi M, Sakairi T, Kaneko Y, Maeshima A, Yamazaki Y, et al. (2018). Hepatitis E during tocilizumab therapy in a patient with rheumatoid arthritis: case report and literature review. Case Rep Rheumatol. (63 year old woman with rheumatoid arthritis developed liver test abnormalities 10 months after starting tocilizumab which were found to be due to acute hepatitis E [bilirubin normal, ALT 523 U/L, Alk P 377 U/L, HEV RNA positive, genotype 3], which resolved spontaneously).
Ahn SS, Jung SM, Song JJ, Park YB, Park JY, Lee SW. (2018). Safety of tocilizumab in rheumatoid arthritis patients with resolved hepatitis B virus infection: data from real-world experience. Yonsei Med J. (Among 15 patients with rheumatoid arthritis who were positive for anti-HBc and were treated with tocilizumab without receiving prophylaxis, none developed reactivation of hepatitis B during an average of 9 months of treatment).
Ben Said B, Gerfaud-Valentin M, Seve P. (2018). Fatal DRESS syndrome under tocilizumab treatment for seronegative polyarthritis. J Allergy Clin Immunol Pract. (69 year old woman with seronegative arthritis developed rash, fever and eosinophilia 3 months after starting tocilizumab with liver abnormalities and progressive jaundice [bilirubin 32.8, ALT 511 U/L] and complications of pancytopenia, hemophagocytic syndrome, CMV viremia and death from progressive hepatic failure 4 months after onset).
Papalopoulos I, Fanouriakis A, Kougkas N, Flouri I, Sourvinos G, Bertsias G, Repa A, et al. (2018). Liver safety of non-tumour necrosis factor inhibitors in rheumatic patients with past hepatitis B virus infection: an observational, controlled, long-term study. Clin Exp Rheumatol. (Among 212 patients with rheumatic disease and anti-HBc without HBsAg in serum who were treated with biologic agents without HBV prophylaxis for an average of 24 months, 1 of 39 on abatacept, 1 of 32 on rituximab, but none of 30 on tocilizumab or 111 on anti-TNF agents developed hepatitis B reactivation).
Sonneveld MJ, Murad SD, van der Eijk AA, de Man RA. (2019). Fulminant liver failure due to hepatitis B reactivation during treatment with tocilizumab. ACG Case Rep J. (59 year old Chinese woman with rheumatoid arthritis and HBsAg in serum [HBV DNA 88 IU/mL] on prednisone, leflunomide and hydroxychloroquine developed clinically apparent reactivation of hepatitis B shortly after starting tocilizumab [bilirubin rising to 25.3 mg/dL, peak ALT 2125 U/L, HBV DNA 3.6 billion IU/mL] and despite starting entecavir developed progressive liver failure and underwent successful liver transplantation).
Brazdilova K, Koller T, Killinger Z, Payer J. (2019). Prevalence and risk factors for drug-induced liver injury among patients with rheumatic diseases treated with biological therapy: a single-center experience. Physiol Res. (Among 199 patients with rheumatic diseases treated with biologic agents, 51 [26%] had ALT elevations during therapy including 24 of 96 [25%] on tocilizumab, but elevations were mostly mild and transient, only 3 patients had values above 3 times ULN none of whom were receiving tocilizumab).
Xu X, Han M, Li T, Sun W, Wang D, Fu B, Zhou Y, et al. (2020). Effective treatment of severe COVID-19 patients with tocilizumab. Proc Natl Acad Sci U S A. (Among 21 patients with severe or critical COVID-19 pneumonia treated with tocilizumab [1 to 2 doses of 400 to 800 mg iv], most patients showed subsequent improvements; no mention of adverse events).
Stone JH, Frigault MJ, Serling-Boyd NJ, Fernandes AD, Harvey L, Foulkes AS, Horick NK, et al., BACC Bay Tocilizumab Trial Investigators. (2020). Efficacy of tocilizumab in patients hospitalized with Covid-19. N Engl J Med. (Among 243 patients hospitalized with severe COVID-19 requiring oxygen who received one dose of tocilizumab or placebo, rates of intubation or death at 28 days were similar [10.6% vs 12.5%], as was time to improvement and adverse event rates including ALT elevations above 5 times ULN [5% vs 4.9%]).
Salama C, Han J, Yau L, Reiss WG, Kramer B, Neidhart JD, Criner GJ, et al. (2021). Tocilizumab in patients hospitalized with Covid-19 pneumonia. N Engl J Med. (Among 377 patients hospitalized with COVID-19 who were treated with tocilizumab vs placebo, duration of hospitalization was shorter with tocilizumab [6 vs 7.5 days], but overall mortality rates were similar [11.6% vs 11.8%] as were total and severe adverse event rates; no mention of ALT elevations or hepatotoxicity).
Salvarani C, Dolci G, Massari M, Merlo DF, Cavuto S, Savoldi L, Bruzzi P, et al., RCT-TCZ-COVID-19 Study Group. (2021). Effect of tocilizumab vs standard care on clinical worsening in patients hospitalized with COVID-19 pneumonia: a randomized clinical trial. JAMA Intern Med. (Among 126 patients hospitalized for COVID-19 and treated with tocilizumab [2 doses, 8 mg/kg] or standard of care, rates of clinical worsening were similar [28% vs 27%], mortality rates were low [3.3% vs 1.5%] but adverse events were more frequent with tocilizumab [23% vs 11%] including ALT elevations [8% vs 3%], but no clinically apparent liver injury).
Hermine O, Mariette X, Tharaux PL, Resche-Rigon M, Porcher R, Ravaud P, CORIMUNO-19 Collaborative Group. (2021). Effect of tocilizumab vs usual care in adults hospitalized with COVID-19 and moderate or severe pneumonia: a randomized clinical trial. JAMA Intern Med. (Among 130 patients hospitalized with COVID-19 and requiring oxygen but not on mechanical ventilation who were randomized to receive tocilizumab or usual care, there were some differences in intermediate outcomes, but the overall mortality rate was the same [11.1% vs 11.9%] as were total and serious adverse event rates; no mention of ALT elevations or hepatotoxicity).
REMAP-CAP Investigators. (2021). Interleukin-6 receptor antagonists in critically ill patients with Covid-19. N Engl J Med. (Among 895 patients hospitalized with severe COVID-19 and starting on organ support, the number of organ support days were fewer with tocilizumab and sarilumab therapy than with usual care, as was the in-hospital mortality rate while severe adverse event rates were similar).
Rosas IO, Bräu N, Waters M, Go RC, Hunter BD, Bhagani S, Skiest D, et al. (2021). Tocilizumab in hospitalized patients with severe Covid-19 pneumonia. N Engl J Med. (Among 438 patients hospitalized with severe COVID-19 treated with either one and possibly two doses of tocilizumab or placebo, improvement in clinical status was similar in both groups as was the mortality rate at 28 days [19.7% vs 19.4%], and as were the total and serious adverse event rates including a “hepatic event” in 1.7% vs 2.1% [ALT or AST above 3 times ULN and bilirubin more than twice normal]).
RECOVERY Collaborative Group. (2021). Tocilizumab in patients admitted to hospital with COVID-19 (RECOVERY): a randomised, controlled, open-label, platform trial. Lancet. (Among 4116 hospitalized adults with COVID-19 and hypoxia who had evidence of systemic inflammation [elevation in serum C-reactive protein], those treated with tocilizumab [single injection of 400 or 800 mg with option for a second dose 12-24 hours later] had a lower 28-day mortality rate compared to those allocated to standard care [31% vs 35%] and were more likely to be discharged by 28 days, while there were no hepatic serious adverse events or deaths attributed to tocilizumab therapy).

## OTHER REFERENCE LINKS

1 Recent References on Tocilizumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Tocilizumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Tocilizumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Tocilizumab)